# Temsirolimus

## OVERVIEW

### Introduction

Temsirolimus is an inhibitor of cell proliferation and anticancer agent that is used as treatment of advanced renal cell cancer. Temsirolimus therapy is frequently associated with mild serum enzyme elevations, but has yet to be linked to instances of clinically apparent liver injury with jaundice.

### Background

Temsirolimus (tem" sir oh' li mus) is an ester of sirolimus, both of which bind to the same intracellular receptor as tacrolimus and cyclosporine, but which block the "mammalian target of rapamycin" (mTOR) rather than calcineurin. mTOR is a serine/threonine kinase which plays an important role in signaling pathways of several cytokines and growth factors, which are involved in carcinogenesis and cancer progression. Inhibition of mTOR causes a decrease in protein synthesis and cell cycle arrest. Temsirolimus therapy has been shown to inhibit progression and prolong survival in patients with advanced and metastatic renal cell cancer. Temsirolimus was approved for use in the United States in 2007 and current indications are limited to therapy of advanced renal cell cancer. Temsirolimus is being actively investigated as therapy of other solid tumors. Temsirolimus is available as liquid solution for injection in vials of 25 mg/mL under the brand name of Torisel. The recommended dose is 25 mg intravenously once weekly until disease progression or unacceptable toxicity. Temsirolimus has many, largely dose dependent, side effects including hypersensitivity reactions, oral ulcers, diarrhea, nausea, poor appetite, fatigue, peripheral edema, rash, and anemia. Uncommon but potentially severe adverse events include hyperglycemia, thrombocytopenia, hypophosphatemia, hyperlipidemia, interstitial pneumonitis and severe hypersensitivity reactions including Stevens Johnson syndrome and angioedema.

### Hepatotoxicity

Serum aminotransferase elevations occur in 30% to 40% and alkaline phosphatase in 60% to 70% of patients receiving temsirolimus, but the abnormalities are usually mild, asymptomatic and self-limiting, rarely requiring dose modification or discontinuation. Elevations of liver enzymes above 5 times the upper limit of normal occur in only 1% to 3% of patients. Since approval and wide spread clinical use, there have been no case reports of clinically apparent liver injury attributed to temsirolimus use. Temsirolimus, like sirolimus, is immunosuppressive, and reactivation of hepatitis B is considered a possible complication of therapy. Yet despite more than 10 years of clinical use, there have been no reports of reactivation of hepatitis B attributed to temsirolimus therapy. Thus, acute liver injury with jaundice due to temsirolimus is probably quite rare, if it occurs at all. Hypersensitivity reactions to temsirolimus infusions are not uncommon (for which reason premedication with an antihistamine is recommended) and instances of Stevens Johnson syndrome have been reported.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

Temsirolimus undergoes extensive hepatic metabolism, largely via the cytochrome P450 system (CYP 3A4). Liver injury might be due to a direct effect of temsirolimus or to a toxic intermediate of its metabolism. Temsirolimus is prone to drug-drug interactions if used with inhibitors or inducers of the cytochrome P450 drug metabolizing enzyme CYP 3A4.

### Outcome and Management

Acute, symptomatic liver injury associated with temsirolimus therapy has not been described, and the serum enzyme elevations associated with its use are usually mild and transient, resolving spontaneously or with dose modification. Because temsirolimus can lead to reactivation of chronic hepatitis B, routine screening of patients for HBsAg before starting therapy is advisable. Patients who develop reactivation should be treated with an oral nucleoside analogue with potent activity against hepatitis B (entecavir or tenofovir). Temsirolimus is an ester of and partially metabolized to sirolimus and cross sensitivity to adverse effects between these two agents is likely. Whether such cross sensitivity extends to other inhibitors of mTOR (such as everolimus) or calcineurin (cyclosporine, tacrolimus) is not known.

Drug Class: Antineoplastic Agents, Miscellaneous; Transplant Drugs

Other Drugs with Similar Intracellular Actions: Cyclosporine, Everolimus, Mycophenolate, Sirolimus, Tacrolimus

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Temsirolimus – Generic, Torisel®

DRUG CLASS

Antineoplastic Agents; Transplant Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Temsirolimus)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Temsirolimus | 162635-04-3 | C56-H87-N-O16

## ANNOTATED BIBLIOGRAPHY

References updated: 04 November 2020

Zimmerman HJ. Cyclosporine. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp.697-8. (Expert review of hepatotoxicity published in 1999 before the availability of temsirolimus).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hillal-Dandan R, Knollmann BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
Hudes G, Carducci M, Tomczak P, Dutcher J, Figlin R, Kapoor A, Staroslawska E, et al. (2007). Global ARCC Trial. Temsirolimus, interferon alfa, or both for advanced renal-cell carcinoma. N Engl J Med. (Controlled trial of temsirolimus vs interferon alfa vs the combination in 626 patients with advanced renal cell carcinoma found prolongation of survival with temsirolimus compared to interferon [10.9 vs 7.3 months]; AST elevations occurred in 8% [>5 times ULN in 1%] of temsirolimus vs 14% of interferon [>5 times ULN in 4%] treated subjects).
Bellmunt J, Szczylik C, Feingold J, Strahs A, Berkenblit A. (2008). Temsirolimus safety profile and management of toxic effects in patients with advanced renal cell carcinoma and poor prognostic features. Ann Oncol. (Analysis of adverse events reported in trials of temsirolimus therapy of renal carcinoma; no discussion of hepatotoxicity or serum enzyme elevations).
Simpson D, Curran MP. (2008). Temsirolimus: in advanced renal cell carcinoma. Drugs. (Concise review of the mechanism of action, pharmacology, efficacy and safety of temsirolimus in advanced renal cell carcinoma; no mention of serum enzyme elevations or hepatotoxicity).
Bhatia S, Thompson JA. (2009). Temsirolimus in patients with advanced renal cell carcinoma: an overview. Adv Ther. (Review of the mechanism of action, efficacy and safety of temsirolimus mentions that therapy is associated with elevations in ALT and Alk P, but does not mention clinically apparent liver injury).
Hudes GR, Berkenblit A, Feingold J, Atkins MB, Rini BI, Dutcher J. (2009). Clinical trial experience with temsirolimus in patients with advanced renal cell carcinoma. Semin Oncol. (Review of results of clinical trials of temsirolimus in advanced renal cell carcinoma; no mention of hepatotoxicity or serum enzyme elevations).
Knox JJ, Qin R, Strosberg JR, Tan B, Kaubisch A, El-Khoueiry AB, Bekaii-Saab TS, et al. (2015). A phase II trial of bevacizumab plus temsirolimus in patients with advanced hepatocellular carcinoma. Invest New Drugs. (Among 28 patients with advanced hepatocellular carcinoma treated with temsirolimus, only 5 patients had a partial response and adverse events were common including fatigue, cytopenias, mucositis, diarrhea and bleeding episodes; no mention of ALT elevations but liver function was maintained).
Yeo W, Chan SL, Mo FK, Chu CM, Hui JW, Tong JH, Chan AW, et al. Phase I/II study of temsirolimus for patients with unresectable hepatocellular carcinoma (HCC)- a correlative study to explore potential biomarkers for response. BMC Cancer 20152; 15: 395. (Among 36 patients with advanced hepatocellular carcinoma treated with temsirolimus in an open label phase II study, only one patient had a partial response and adverse events included mucositis, rash, fatigue, cough, fever, anorexia, insomnia, diarrhea, thrombocytopenia, abdominal and head pain, hyperglycemia, and thrombocytopenia; no mention of ALT elevation or change in hepatic status).
Minguet J, Smith KH, Bramlage CP, Bramlage P. (2015). Targeted therapies for treatment of renal cell carcinoma: recent advances and future perspectives. Cancer Chemother Pharmacol. (Review of current and future targeted therapies for renal cancer discusses tyrosine kinase inhibitors and mTor inhibitors including everolimus and temsirolimus; no mention of ALT elevations or hepatotoxicity).
Dreyling M, Jurczak W, Jerkeman M, Silva RS, Rusconi C, Trneny M, Offner F, et al. (2016). Ibrutinib versus temsirolimus in patients with relapsed or refractory mantle-cell lymphoma: an international, randomised, open-label, phase 3 study. Lancet. (Among 280 patients with refractory mantle cell lymphoma treated with temsirolimus or ibrutinib, progression free survival was longer with ibrutinib [14.6 vs 6.2 months], which was also better tolerated; no mention of ALT elevations or hepatotoxicity of either drug).
Pulido M, Roubaud G, Cazeau AL, Mahammedi H, Vedrine L, Joly F, Mourey L, et al. (2018). Safety and efficacy of temsirolimus as second line treatment for patients with recurrent bladder cancer. BMC Cancer. (Among 54 patients with bladder cancer treated with temsirolimus, partial responses occurred in 3 and the authors concluded that temsirolimus “had potential benefit for a subset of bladder cancer patients”; no mention of ALT elevations or hepatotoxicity).
Sugiyama S, Sato K, Shibasaki Y, Endo Y, Uryu T, Toyoshima Y, Oya M, et al. (2020). Real-world use of temsirolimus in Japanese patients with unresectable or metastatic renal cell carcinoma: recent consideration based on the results of a post-marketing, all-case surveillance study. Jpn J Clin Oncol. (Among 1001 Japanese patients with renal cancer treated with temsirolimus followed in a postmarketing study, 78% had adverse events, most commonly stomatitis [27%], interstitial lung disease [17%], thrombocytopenia [17%], hyperglycemia [10%], and rash [7%], but no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Temsirolimus: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Temsirolimus/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Temsirolimus: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Temsirolimus)